# Ajmaline

## OVERVIEW

### Introduction

Ajmaline is an anti-arrhythmic alkaloid derived from the roots of Rauwolfia serpentina, an evergreen shrub native to India, Indochina and Borneo. Purified, concentrated ajmaline and an orally formulated prodrug of ajmaline have been used in Europe and Japan as an antiarrhythmic agent where it has been linked to cholestatic liver injury which can be severe and prolonged.

### Background

Ajmaline (ahj” ma line) is an alkaloid with potent antiarrhythmic activities that is isolated from extracts of the roots of Rauwolfia serpentina, an evergreen shrub native to India, Indochina, and Borneo. Purified and concentrated ajmaline has been used as an antiarrhythmic agent for decades in Europe and Asia. However, it was never approved for use in the United States. It is classified as a class 1A antiarrhythmic agent similar to quinidine and has been used to treat atrial fibrillation, ventricular arrythmias, and Wolff-Parkinson-White syndrome. It is also used in electrophysiologic studies for the diagnosis of Brugada syndrome, a genetic channelopathy associated with fatal ventricular arrhythmias. Ajmaline is poorly absorbed by mouth and is currently available in several countries as a solution for intravenous administration (trade name Gilurytmal and others). Prajmalium bitartrate (N-propyl ajmaline bitartrate), a semisynthetic prodrug of ajmaline, was developed for oral administration (trade name NeoGilurytmal). The use of ajmaline and prajmalium has decreased in recent years with the availability of safer and more effective antiarrhythmic agents. Common side effects of intravenous ajmaline include bradycardia, hypotension, and arrhythmias. Potential serious adverse events of oral ajmaline and prajmalium include ventricular arrhythmias, agranulocytosis, aplastic anemia, and cholestatic liver disease.

### Hepatotoxicity

There is little information on the safety of herbal products produced from Rauwolfia serpentina but extracts have been shown to contain several bioactive alkaloids including ajmaline and reserpine. These compounds, however, make up only a small fraction of the constituents of the herbal extracts. Ajmaline that is used as an antiarrhythmic agent is purified and concentrated, so that it acts more like a drug than a traditional herbal product. Ajmaline and its prodrug prajmalium have been implicated in more than 100 cases of liver injury reported in the literature, mostly from Europe, the Middle East, and Japan. The latency to onset is usually 1 to 3 weeks, and it typically presents with fever, chills, abdominal discomfort, fatigue, and nausea with improvements within 1 to 2 weeks, but this is followed by dark urine, pruritus, and jaundice. At onset bilirubin levels can be as high as 25 mg/dL, ALT and AST being 1 to 10 times ULN, and alkaline phosphatase 2 to 5 times ULN. Eosinophilia is frequent but not invariable. Autoantibodies are not common. While serum aminotransferases can be quite high at onset, the overall course of the liver injury is usually cholestatic. Liver biopsy typically reveals varying degrees of centrilobular cholestasis and mild inflammation including eosinophils. Histologic evidence of bile duct injury and, more rarely, bile duct loss can also be found. The symptoms and biochemical abnormalities usually resolve rapidly once the drug is stopped, but in some cases, symptoms and jaundice persist for months and occasionally fulfill criteria for vanishing bile duct syndrome with persistence of liver tests abnormalities and symptoms for years. Strikingly, cases of cholestatic hepatitis have been described after administration of a single dose of intravenous ajmaline during electrophysiologic studies for eliciting evidence of Brugada syndrome. Fatal cases of ajmaline-induced cholestatic hepatitis have also been reported but are rare. Thus, ajmaline and prajmalium are rare but well-known causes of clinically apparent, immune allergic cholestatic hepatitis. Interestingly, the clinical phenotype of ajmaline induced liver injury is like that of quinidine, a structurally unrelated, class 1A antiarrhythmic agent.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ajmaline and prajmalium cause liver injury is not known but appears to be due to hypersensitivity with initial prominence of fever and eosinophilia and rapid recurrence (within 1 to 4 days) upon rechallenge. HLA associations have not been reported.

### Outcome and Management

Ajmaline and prajmalium bitartrate induced liver injury is generally self-limited in course but can result in prolonged cholestasis. Corticosteroid therapy is of uncertain benefit and is probably best avoided. Cross sensitivity to other antiarrhythmics has not been reported but restarting ajmaline results in rapid recurrence of injury and should be avoided.

Drug Class: Antiarrhythmic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ajmaline – generic, Gilurytmal, Ritmos, Aritmina

Prajmalium bitartrate - NeoGilurytmal

DRUG CLASS

Antiarrhythmic Agents

Product labeling at DailyMed not available, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ajmaline | 4360-12-7 | C20H26N2O2 | SID: 505548942

## ANNOTATED BIBLIOGRAPHY

References updated: 30 June 2026

Abbreviations used: ULN, upper limit of normal.

Zimmerman HJ. Ajmaline. Antiarrhythmic Agents. In, Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: 512-13. (Expert review of hepatotoxicity published in 1999, mentions that ajmaline is an alkaloid derived from the root of Rauwolfia serpentina, that has structural similarity to quinidine and has been incriminated in at least 30 cases of cholestatic jaundice, from Europe and Asia).
Rauwolfia: Rauwolfia serpentina. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 691-2. (Compilation of short monographs on herbal medications and dietary supplements does not discuss hepatotoxicity of Rauwolfia serpentina).
Doelle W. [Intrahepatic cholestasis by Ajmaline]. Med Klin. 1962;57:1648-50. German. PMID: 14028329 (First report of cholestatic hepatitis due to ajmaline in 2 women, ages 61 and 49 years, who had been taking ajmaline [50 and 20 mg twice daily] for 10 days and 6 weeks and presented with chills, fever, fatigue, dark urine, and then jaundice [bilirubin 4.8 and 1.8 mg/dL, AST 53 and 58 U/L, Alk P 2-4 times ULN, eosinophils 4% and 14%] with biopsies showing cholestasis and gradual but complete resolution with stopping).
Beermann B, Ericsson JL, Hellström K, Wengle B, Werner B. Transient cholestasis during treatment with ajmaline, and chronic xanthomatous cholestasis after administration of ajmaline, methyltestosterone and ethinylestradiol. Two case reports. Acta Med Scand. 1971;190:241-50. PMID: . (Two cases of fever and abdominal distress followed by itching and jaundice arising 6 and 10 days after starting ajmaline, the first case improving rapidly on stopping therapy [with rapid recurrence on rechallenge], and the second case [also exposed to methyltestosterone and estrogen] with prolonged elevations in Alk P and bilirubin and chronic liver disease despite stopping therapy, suggestive of vanishing bile duct syndrome). 5124256
Einarsson K, Hellström K, Kallner M. Leverskada i samband med ajmalin-behangling [Liver damage in connection with ajmaline treatment]. Lakartidningen. 1973;70:1288-90. Swedish. PMID: 4699013 (4 patients with intrahepatic cholestasis, 2 men and 2 women, ages 51 to 83 years, developed jaundice 1, 6, 10 and 59 days after starting ajmaline with rapid resolution in two, slow resolution in one, and persistence of cholestasis for years with development of biliary cirrhosis in one).
Henning H, Vogel HM, Ihlenfeld J, Buchegger K, Lüders CJ. Leberschäden unter N-Propyl-Ajmalin-Bitartrat (NPAB) [Liver damage due to N-propyl-ajmalin bitartrate (NPAB)]. Z Gastroenterol. 1975;13:501-6. German. PMID: 1189511 (Description of two cases of suspected liver injury due to Prajmalium bitartrate who had a positive rechallenge, led the authors to prospective study of 27 treated patients, 4 of whom developed biochemical evidence of liver injury 13 to 20 days after starting Prajmalium).
Buscher HP, Talke H, Rademacher HP, Gessner U, Oehlert W, Gerok W. Intrahepatische Cholestase durch N-Propyl-Ajmalin [Intrahepatic cholestasis due to N-propyl ajmaline]. Dtsch Med Wochenschr. 1976;101:699-703. German. PMID: 1261401 (42 year old man and 34 year old woman developed cholestatic hepatitis arising within a month of starting ajmaline [bilirubin 7.0 and 5.6 mg/dL, ALT 180 and 280 U/L, Alk P 2 and 3 times ULN], both with eosinophilia, one with fever and both resolving within 1-2 months of stopping).
Lindner H, Weber D, Klöppel G. Prajmaliumbitartrat-induzierte Leberschäden [Prajmalium bitartrat-induced liver damage (author's transl)]. Dtsch Med Wochenschr. 1976;101:1876-80. German. PMID: 1001207 (5 patients, 3 men and 2 women, developed jaundice 1 to 4 weeks after starting oral prajmalium often presenting with fever and abdominal pain with jaundice and cholestatic course).
Hecht Y, Rigaud D, Ferrier JP, Celerier M, Leclerc JP. Hépatite cholestatique et congestion lymphatique du foie imputables à l'ajmaline. Guérison par la spironolactone d'une cholestase complète? [Cholestatic hepatitis and lymphatic liver congestion caused by ajmaline. Resolution of complete cholestasis with spironolactone?]. Nouv Presse Med. 1977;6(45):4204-5. French. PMID: 609539 (47 year old woman developed fever, chills, abdominal pain, and jaundice 20 days after starting ajmaline and butobarbital [bilirubin 2.0 rising to 15.5 mg/dL, eosinophils 15%, ALT and Alk P not given], and laparotomy demonstrated lymphocyte-rich ascites, an enlarged liver with engorged lymphatics, and liver histology showing cholestasis and inflammatory infiltrates with many eosinophils, the injury resolving quickly when spironolactone was started for the ascites).
Hecht Y, Rigaud D, Celerier M, Leclerc JP, Ferrier JP. Hépatite cholestatique à l'ajmaline. Congestion lymphatique du foie. Guerison par la spironolactone d'une cholestase complete [Cholestatic hepatitis due to ajmaline. Lymphatic congestion of the liver. Recovery after spironolactone]. Med Chir Dig. 1978;7:473-4. French. PMID: 732373 (Same case as described in Hecht 1977).
Weiss M, Theodor E, Bank H. Hépatotoxicity due to n-propyl ajmaline bitartrate. Report of a case. Med Chir Dig. 1978;7:527-8. PMID: . (76 year old man developed fever and rash followed by jaundice 2 months after starting prajmalium bitartrate [bilirubin 16.6 mg/dL, AST 265 U/L, Alk P 315 U/L, eosinophils normal] with resolution with 1-2 months of stopping and rapid recurrence within 4 days of restarting [bilirubin 3.0 mg/dL, AST 200 U/L, Alk P 216 U/L]). 732381
Pariente EA, Pessayre D, Bentata-Pessayre M, Capron JP, Marti R, Delcenserie R, Callard P, Benhamou JP. Hépatite à l'ajmaline. Description de 4 observations et revue de la littérature [Hepatitis due to ajmaline. Report of cases and review of the literature]. Gastroenterol Clin Biol. 1980;4:240-5. French. PMID: 7188270. (Four cases of immunoallergic, cholestatic hepatitis arising with fever and abdominal pain 10 to 18 days after starting ajmaline followed by pruritus and jaundice [bilirubin 4.2 to 27.5 mg/dL, ALT 2 to 18 times ULN, Alk P 2 to 3 times ULN] with eosinophilia in 3 cases, liver biopsy showing cholestasis, inflammation, and in 3 cases necrosis, rechallenge leading to rapid recurrence in 3 patients, and all recovering without residual injury).
Rotmensch HH, Liron M, Yust I, Klejman A, Livni E, Moalem T, Gefel A. Cholestatic jaundice: an immune response to prajmalium bitartrate. Postgrad Med J. 1980;56:738-41. PMID: (50 year old man with a myocardial infarction was treated with iv ajmaline, was switched to oral prajmalium bitartrate [an oral prodrug of ajmaline], and developed fatigue, chills, itching, and jaundice 20 days later [bilirubin ~5.3 mg/dL, ALT 140 U/L, Alk P 150 U/L], symptoms and liver tests improving rapidly with stopping, and recurring within one day of a single, low oral dose, again resolving rapidly). 7220413
Rubinstein E, Dejgård A, Duus B. Ajmalin-induceret hepatitis i Danmark [Ajmaline induced hepatitis in Denmark]. Ugeskr Laeger. 1981;143:3304-5. Danish. PMID: 7331043. (Between 1975 and 1980, 9 cases of intrahepatic cholestasis following use of ajmaline was reported to a Danish national registry in 6 women and 3 men, ages 35 to 82 years, after 8 days to 4 years of taking ajmaline for arrhythmias, one with pancytopenia lasting for 3 months, one who had esophageal varices 1 year later, and one with symptomatic cholestasis lasting 5 months).
Naschitz JE, Bassan H, Yeshurun D, Boss JH. Ajmalin-induzierte Leberschäden [Liver damage caused by ajmalin (author's transl)]. Leber Magen Darm. 1981;11:264-8. German. PMID: 6172687. (5 Israeli patients, 4 men and 1 women, ages 50 to 71 years, after 6 to 15 days of taking prajmalium bitartrate [30 to 60 mg/day], presented with abdominal pain and weakness, [bilirubin 1.0 to 5.2 mg/dL, AST 65 to 170 U/L, Alk P 1.2 to 2.3 times ULN, 4 with eosinophilia], improvements occurring within a few days of stopping).
Rotmensch HH, Leiser A, Dan M, Klejman A, Livni E, Ilie B, Messer G, Kadish U, Liron M. Evaluation of prajmalium-induced cholestasis by immunologic tests. Arch Intern Med. 1981;141:1797-1801. PMID: . (Four cases of cholestatic hepatitis in Israeli patients receiving prajamlium bitartrate with symptoms of chills, fever, fatigue, itching, and jaundice, arising 3 to 20 days after starting oral therapy, with bilirubin 5.3 to 13.8 mg/dL, ALT 32 to 142 U/L, Alk P 138 to 345 U/L, usually resolving rapidly upon stopping and all without chronic sequelae). 7316626
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. 1982;17:205-11. PMID: . (Among 572 cases of hepatotoxicity reported to a Danish national registry between 1968 and 1978, common causes included halothane [25%], chlorpromazine [16%], oral contraceptives [9%], trimethoprim/sulfamethoxazole [7%], oxyphenisatin [4%], methyldopa [2.5%], and ajmaline [1%]). 6982502
Monges B, Monges G, Salducci J. Hépatite à l'ajmaline. Présentation d'un cas avec étude ultrastructurale [Ajmaline-induced hepatitis. a case report with ultrastructural study]. Gastroenterol Clin Biol. 1983;7:540-4. French. PMID: 6873568. (43 year old man developed fever and pruritus followed by jaundice 20 days after starting ajmaline [bilirubin 26 mg/dL, ALT 171 U/L, Alk P 650 U/L], liver biopsy showing cholestasis and electron microscopy demonstrating widened, empty bile canaliculi with blunted microvilli suggesting a disorganization of the peri-canalicular filamentous structures).
Börsch G, Schmidt G, Hopmann G, Surmann T, Sabin G, Ricken D. Prajmaliumbitartrate-associated liver damage. Report on seven further cases with follow-up for two to five years. Klin Wochenschr. 1984;62:998-1000. PMID: (Description of 7 cases of prajmalium induced liver injury arising between 1976 and 1980 in two German medical centers, 4 women and 3 men, ages 26 to 71 years, after 7 to 22 days of prajmalium bitartrate therapy, usually presenting with fever, arthralgias, abdominal pain, and jaundice [bilirubin 0.8 to 27.1 mg/dL, ALT 107 to 900 U/L, Alk P 110 to 628 U/L], all resolving within 1 month of stopping). 6503219
Sameshima Y, Shiozaki Y, Mizuno T, Sasakawa M. [Drug-induced hepatic injury. A review of the Japanese articles for the past 70 years]. Nihon Shokakibyo Gakkai Zasshi. 1984;81:37-45. Japanese. PMID: 6748296. (Among 8156 cases of drug-induced liver injury reported in the Japanese literature between 1911 and 1981, the most common causes were cephalosporins, penicillins, thorium dioxide, arsphenamine, aminoglycosides, ethionamide, rifampin, and macrolides, while ajmaline accounted for 148 cases (only 1 fatal) and ranked in the top 15 causes identified).
Stránský J, Velan J, Kostrhun L, Michálková D, Vozenílek J, Vodák M. Toxické poskození jater ajmalinem [Toxic liver damage caused by ajmaline]. Vnitr Lek. 1985;31):1208-12. Czech. PMID: 4090309 (52 year old man with Wolff-Parkinson-White syndrome developed fever, malaise, and jaundice 10 days after starting ajmaline with bilirubin rising to 26.4 mg/dL and successful treatment with prednisone and spa rehabilitation).
Larrey D, Pessayre D, Duhamel G, Casier A, Degott C, Feldmann G, Erlinger S, Benhamou JP. Prolonged cholestasis after ajmaline-induced acute hepatitis. J Hepatol. 1986;2):81-7. PMID: 3950363 (Three cases of acute cholestatic hepatitis arising 8 to 16 days after starting ajmaline with fever, chills, abdominal pain, followed by jaundice which resolved within 1-4 months of stopping but one patient had persistent fatigue and abnormal ALT, Alk P and GGT elevations were still present 1-2 years later with biopsies showing bile duct paucity).
Polunina TE, Zamotaev IP, Ivlev AS. Trudnosti diagnostiki lekarstvennogo gepatita, vyzvannogo aĭmalinom [Diagnostic difficulties in ajmaline-induced hepatitis]. Kardiologiia. 1987;27:126-7. Russian. PMID: 3695077 (65 year old with atrial fibrillation was started on ajmaline [150 mg daily] and 17 days later was admitted to the hospital for heart failure and found to have jaundice and pruritus [bilirubin 15 mg/dL, ALT 334 U/L, Alk P 323 U/L] which was interpreted as ajmaline induced liver injury).
Ikeda N, Umetsu K, Suzuki T, Gonmori K, Takahashi K. An infant fatality involving ajmaline. J Forensic Sci. 1988;33:558-61. PMID: . (An infant fatality following accidental ingestion of ajmaline is described with serum ajmaline levels determined by thin-layer chromatography and infrared spectrophotometry and quantitated by high performance liquid chromatography at 5.5 μg/mL). 3373173
Lenzen R, Gottesbüren H, Borchard F, Wienbeck M, Strohmeyer G. Intrahepatische Cholestase und aplastische Anämie nach Prajmalin-Einnahme [Intrahepatic cholestasis and aplastic anemia following administration of prajmaline]. Klin Wochenschr. 1988;66:264-70. German. PMID: 2452916. (43 year old woman developed fever, weakness, and arthralgias followed by pruritus, dark urine, and jaundice with an accompanying pure red cell aplasia and persistent severe cholestasis [initially bilirubin 9.8 mg/dL, ALT 248 U/L, Alk P 313 U/L, and Hgb 6.8 g/L]; the anemia resolved with corticosteroid therapy, but liver injury worsened over the next few months, [bilirubin rising to 64.9 mg/dL, Alk P to 6216 U/L], and bilirubin and aminotransferases remained elevated for 4 years and pruritus for 5 years, while Alk P remained high [602 U/L] even ten years later).
Chammartin F, Levillain P, Silvain C, Chauvin C, Beauchant M. Hépatite prolongée à l'ajmaline--description d'un cas et revue de la littérature [Prolonged hepatitis due to ajmaline--description of a case and review of the literature]. Schweiz Rundsch Med Prax. 1989;78:582-4. French. PMID: 2568014 (60 year old woman developed fever followed by jaundice and itching 15 days after starting ajmaline [bilirubin 13.2 mg/dL, ALT 801 U/L, Alk P 1320 U/L, eosinophils 7%] with persistence of jaundice and pruritus for 3 years and liver test abnormalities for 5 years [bilirubin 1.0 mg/dL, ALT 106 U/L, Alk P 980 U/L]).
Bołdys H, Nowak A, Hartleb M, Wieczorek M. Trudności diagnostyczne śródwatrobowego zastoju zółci wywołanego zazywaniem prajmalium [Diagnostic difficulties in prajmaline-induced intrahepatic cholestasis]. Pol Tyg Lek. 1990;45(16-18):353-4. Polish. PMID: 2235724. (Abstract: The diagnosis of prajmalium-induced intrahepatic cholestasis was delayed but clinical and biochemical features resolved within a year of eventually stopping therapy).
Azzam Z, Krivoy N. [Transient liver damage due to prajmalium bitartrate]. Harefuah. 1991;120:17-8. Hebrew. PMID: 2010122. (Two women and one man, ages 27-58 years, developed fever followed by pruritus and jaundice 10 to 30 days after starting prajmalium bitartrate [bilirubin 1.6, 7.8, and 20.4 mg/dL; AST 62-100 U/L; Alk P 55-220 U/L, eosinophils 7%-10%], and improvement on stopping drug and biochemical resolution in 1, 4 and 6 months).
Pras E, Steinlauf S, Sidi Y. [Preajmaline-induced cholestatic hepatitis]. Harefuah. 1991;121:380-1. Hebrew. PMID: 1752555. (Two cases: 40 year old woman developed fever, nausea, anorexia, and weakness a week after starting prajmalium followed by jaundice and pruritus [bilirubin 11.7 mg/dL, AST 120 U/L, Alk P 287 U/L] with rapid improvement within a month of stopping; 74 year old man developed fever, nausea, and abdominal pain 2 weeks after starting prajmaline followed by jaundice and pruritus [bilirubin 16 rising to 36 mg/dL, ALT 175 U/L, AST 173 U/L, Alk P 336 U/L], with slow but complete resolution 8 months after stopping).
Prokopowicz D, Lapiński TW. Hepatotoksyczny efekt uboczny Neo-Gilurytmalu uzasadniajacy podejrzenie o wirusowe zapalenie watroby--opis przypadku [Hepatotoxic side effect of n-propylajmaline suggesting suspicion of viral hepatitis--case history]. Przegl Epidemiol. 1993;47:471-3. Polish. PMID: 8171211 (28 year old woman developed fever, nausea, and abdominal pain 10 days after starting prajmalium followed by jaundice and pruritus [bilirubin 3.9 mg/dL, ALT 295 U/L, Alk P 210 U/L] with rapid complete recovery within a month of stopping).
Trefanec J, Langmeierová M, Zelezná J. Akutní anikterická hepatitida s intrahepatální cholestázou vyvolaná podáváním prajmalium bitartarátu (Neo-Gilurytmal) [Acute anicteric hepatitis and intrahepatic cholestasis caused by administration of prajmalium bitartrate (Neo-Gilurytmal)]. Cas Lek Cesk. 1994;133:83-5. Czech. PMID: 8137378. (Two cases: 70 year old man developed fever, fatigue, and dark urine 4 weeks after starting prajmalium [bilirubin 1.2 mg/dL, ALT 252 U/L, Alk P 336 U/L] which resolved within 4 weeks of stopping; 21 year old woman developed fever, abdominal pain, and weakness 17 days after starting prajmalium [bilirubin 1.5 mg/dL, ALT 546 U/L, Alk P 207 U/L] resolving 8 weeks after stopping the medication).
Piekarska A. Cholestatyczne zapalenie watroby wywołane zastosowaniem prajmaliny--opis przypadku [Cholestatic hepatitis caused by prajmalium treatment: case report]. Pol Arch Med Wewn. 2003;109:629-32. Polish. PMID: 14567096. (Abstract: Cholestatic hepatitis occurred three weeks after stopping a short course of prajmalium with persistence of abnormal liver tests for more than a year, liver biopsy showing chronic canalicular cholestasis with lymphocytic infiltration).
Mellor G, Fellows I, Williams I. ‘Intrahepatic cholestatic hepatitis following diagnostic ajmaline challenge'. Europace. 2013;15:314. PMID: (54 year old woman received a single iv dose of ajmaline [1 mg/kg] for electrophysiologic diagnosis of Brugada syndrome and developed pruritus, dark urine, and jaundice 3 weeks later [bilirubin rising to ~10 mg/dL, ALT~550 U/L, Alk P ~450 U/L] liver tests improving upon stopping but remaining elevated for several months). 22804909
Mullish BH, Fofaria RK, Smith BC, Lloyd K, Lloyd J, Goldin RD, Dhar A. Severe cholestatic jaundice after a single administration of ajmaline; a case report and review of the literature. BMC Gastroenterol. 2014;14:60. PMID: (33 year old man underwent ajmaline provocation testing for Brugada syndrome and developed pruritus and jaundice 3 weeks later [bilirubin 14.2 mg/dL, ALT 90 U/L, Alk P 309 U/L] with slow recovery and minor liver test abnormalities still present one year later). 24694003
Hamoir C, Dano H, Komuta M, Druez P, Negrin Dastis S. Cholestatic hepatitis after diagnostic ajmaline challenge. Acta Gastroenterol Belg. 2017;80:425-426. PMID: . (78 year old woman with atrial fibrillation and syncope developed jaundice 1 month after undergoing electrophysiologic challenge screening with a single iv dose of ajmaline [1 mg/kg] for possible Brugada syndrome [bilirubin 7.3 rising to 8.2 mg/dL, ALT 65 U/L, Alk P 230 U/L, INR normal] liver biopsy showing cholestatic hepatitis, resolving with no therapy in 10 weeks). 29560676
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. PMID: (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, none were attributed to ajmaline or prajmalium bitartrate). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ajmaline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ajmaline%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ajmaline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ajmaline)